# Ipratropium

## OVERVIEW

### Introduction

Ipratropium is a synthetic anticholinergic agent that is used as an inhalant for treatment of acute bronchospasm due to chronic bronchitis and emphysema. Ipratropium has not been implicated in causing liver enzyme elevations or clinically apparent acute liver injury.

### Background

Ipratropium (ip" ra troe' pee um) is a synthetic quaternary ammonium anticholinergic which inhibits the muscarinic actions of acetylcholine on autonomic nerve endings, decreasing bronchial smooth muscle contractions and alleviating bronchospasm in patients with chronic obstructive pulmonary disease (COPD). Ipratropium has potent activity against muscarinic acetylcholine type 3 (M3) receptors which are found in bronchial smooth muscle. Its quaternary ammonium structure decreases its ability to cross lipid membranes such as the blood brain barrier. Ipratropium was approved for use in the United States in 1986 as a respiratory inhalant and indications include maintenance treatment of bronchospasm associated with chronic bronchitis and emphysema. Ipratropium is available in various formulations generically and under the brand names Atrovent and Combivent for use as an inhalant. The typical dose in adults is 1 inhalation 3 to 4 times daily. The common side effects of parasympathetic stimulation (such as dryness of the mouth and eyes, decreased sweating, visual blurring, constipation, urinary retention, impotence, tachycardia and palpitations, anxiety and restlessness) are uncommon in patients treated with ipratropium by inhaler. Ipratropium use can cause paradoxical bronchospasm. Anticholinergic agents can precipitate acute narrow angle glaucoma and acute urinary retention.

### Hepatotoxicity

Like other anticholinergic agents, ipratropium has not been linked to episodes of liver enzyme elevations or clinically apparent liver injury. A major reason for its safety may relate to its low systemic absorption when administered by inhaler.

References on the safety and potential hepatotoxicity of anticholinergics are given together after the Overview section on Anticholinergic Agents.

Drug Class: Anticholinergic Agents

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Ipratropium – Generic, Atrovent®

DRUG CLASS

Anticholinergic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Ipratropium)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Ipratropium | 66985-17-9 | C20-H30-Br-N-O3.x-H2-O | Ipratropium Chemical Structure

## OTHER REFERENCE LINKS

1. Recent References on Ipratropium: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Ipratropium/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Ipratropium: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Ipratropium)